# Tara Flour

## OVERVIEW

### Introduction

Tara flour is a protein-rich flour made from the seeds of the Caesalpinia spinosa tree that was found to cause acute gastrointestinal and liver injury when used in a commercial food product called “Daily Harvest’s French Lentil and Leek Crumbles”. Chemical analysis of the product demonstrated the presence of a non-protein amino acid baikiain which caused liver injury when given orally in an animal model and was therefore the likely cause of the liver injury seen in humans who consumed the product.

### Background

Tara flour is a protein-rich flour made from the seeds of the Caesalpinia spinosa tree which is native to Peru and found in several regions in South America. When introduced into a commercial food product called “Daily Harvest’s French Lentil and Leek Crumbles” in April 2022, it caused an outbreak of acute gastrointestinal and liver disease that affected at least 393 people before it was removed from the market in late-June 2022. Chemical analysis of the product demonstrated more than 27 ingredients, none of which were known to cause liver injury. The product was free of evidence of contamination with toxic compounds including microbial or viral pathogens, mycotoxins, allergens, heavy metals, and pesticides. However, among products identified in the crumbles was tara flour which on further analysis was found to be rich in the 3 non-protein amino acids, baikiain (3% dry weight), L-3-hydroxymethyltyrosine (3HMT: 1.5%), and L-3-hydroxymethylphenylalanine (3HMP: 0.5%). Analysis of baikiain in toxicology studies demonstrated that it caused liver injury in mice after oral ingestion with serum ALT levels rising from 31 to 230 U/L within 6 hours. After removal of the tara flour from the commercial product, no further human cases of liver injury were seen. While tara flour had not been known to cause liver injury, similar acute toxic reactions to foods have been seen in the past in grazing animals exposed to plants that synthesize non-protein amino acids, which are analogues of amino acids and result in absent or diminished function of the protein enzymes with the substituted amino acid.

### Hepatotoxicity

The typical clinical onset of tara flour toxicity was with indigestion and variable degrees of abdominal pain, nausea and vomiting within 4 to 12 hours of ingestion, which was sometimes severe enough to result in an emergency room visit or even hospitalization and cholecystectomy. In some patients, symptoms persisted and were followed by fatigue, dark urine, and jaundice two to eight days later. Laboratory testing demonstrated a hepatocellular pattern of serum enzyme elevations with ALT and AST levels in the range of 3 to 20 times the upper limit of normal (ULN) and only mild or no increases in alkaline phosphatase levels. Total serum bilirubin levels were elevated in more severe cases, but generally were rather modest with peak levels of 2.0 to 10.0 mg/dL and rapid improvement within days. In long term follow up of patients, all values returned to the normal or baseline levels. Liver biopsy in one case showed a mild acute hepatitis with lobular inflammation, mild lymphocytic infiltration and no steatosis, fibrosis, or cholestasis. Virtually all cases arose in May and June of 2022 with none appearing after the withdrawal of the food product. However, cases of acute liver injury have also been reported after ingestion of other food products that included tara flour as an ingredient.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of liver injury

Tara flour appears to be a direct hepatotoxin, although its toxicity may depend upon an initial metabolism to a more toxic intermediate or substitution of the non-protein amino acid baikiain into a functional and important enzyme. Baikiain does not harm mammalian or human cells in culture but does cause liver injury and depletion of glutathione is rodent models. The pathways involved in the cell injury have not been fully defined but may be similar to those of acetaminophen which also depletes glutathione which plays a major role in detoxifying injurious substances in the liver. The depletion of glutathione leaves hepatocytes and other cells vulnerable to toxic molecular intermediates of normal cellular metabolism.

### Outcome and Management

Tara flour hepatotoxicity is generally self-limited and only mild-to-moderate in severity. Most important is to identify the cause as being due to ingestion of a food that is responsible and discontinuation of further use as well as avoiding possibly harmful interventions for diagnosis such as liver biopsy, cholecystectomy and even invasive forms of cholangiography. Most appropriate is symptomatic therapy and withdrawal of further possible exposure as the liver injury is self-limited and ultimately resolves completely. While unproven, administration of NAC or a glutathione repleting agent might be appropriate in an attempt to shorten and ameliorate the injury, but currently it must be considered experimental. Such an approach is certainly worthy of laboratory and clinical investigation.

Other Names: Spiny Holdback, Tara spinosa, Tara, Taya, Quechua

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. 37 year old woman with pain and jaundice after eating Daily Harvest’s French Lentil and Leek Crumbles [107-0127].(1)

A 37 year old woman, who had been receiving monthly Daily Harvest frozen food preparations for more than a year, consumed a new product called “French Lentil and Leek Crumbles” for dinner and noted feeling ill with transient stomach pain afterwards. Three days later she consumed more of the product and developed severe stomach pains and nausea followed by constipation the next day which she attributed to stress at work. Six days later she prepared tacos for lunch to which she added the lentil and leek crumbles and again developed severe abdominal pain 4 to 6 hours later. That evening she had body aches and the following morning still felt ill and developed nausea and vomiting. That same day she received notification from Daily Harvest about the potential of the crumbles product to cause liver injury. The following day, she noted that her urine had turned dark, and she sought medical care. Laboratory testing revealed a total bilirubin of 4.3 mg/dL, ALT 810 U/L, AST 226 U/L, alkaline phosphatase 178 U/L (R=14), albumin 4.9 g/dL, and INR 1.1. She enjoyed general good health, had no major medical illnesses, and had no history of liver disease, drug allergies, alcohol use, recent travel, or risk factors for viral hepatitis. Her only medications were cyclobenzaprine and vitamin B12, both of which she had taken for more than a year. Serologic testing revealed no evidence of acute hepatitis A, B, C, or E nor of acute EBV infection. The ANA was positive (1:320), but SMA and AMA were negative and total globulins (2.9 g/L) and IgG levels (1011 mg/dL) were normal. An abdominal ultrasound showed no evidence of biliary obstruction and a normal gall bladder without stones. The ultrasound also showed hyperechogenicity suggestive of hepatic steatosis, even though her BMI was 21.4 kg/m^2^, and cholesterol, triglycerides, and fasting blood sugar were normal. Over the next 2 to 3 weeks both her symptoms and liver test abnormalities resolved (Table). In follow up 1, 4, and 7 months later, her liver test results were normal, although ANA remained positive (1:160) and repeat ultrasound showed echogenicity suggestive of steatosis.

#### Key Points

Medication: | French Lentil and Leek Crumbles
Pattern: | Hepatocellular (R=14)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 1 day to symptoms, 10 to jaundice
Recovery: | 2-3 weeks
Other medications: | Cyclobenzaprine, vitamin B12

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 day | Pre | First meal with FLLC
3 days | Pre | Second dinner with FLLC
9 days | 0 | Third meal (lunch) with FLLC
10 days | 1 day | Ill with abdominal pain, nausea, and fatigue
11 days | 2 days | 810 | 178 | 4.3 | INR 1.1, R=14
2 weeks | 5 days | 240 | 140 | 1.0 | R=5.5, ANA 1:320
| 2 weeks | 59 | 77 | 0.7
1 month | 3 weeks | 23 | 56 | 0.7 | Normal
| 5 weeks | 19 | 48 | 0.3
| 4 months | 13 | 45 | 0.6 | ANA 1:320
| 7 months | 29 | 42 | 0.7
8 months | 7.6 months | 27 | 46 | 0.7 | ANA 1:160
Normal Values | | <35 | <115 | <1.2

#### Comment

An otherwise healthy woman who had subscribed to a Daily Harvest foods program for more than a year, became acutely ill after ingesting a new product called “French Lentil and Leek Crumbles” on three occasions. The symptoms resolved after the first two exposure to the crumbles, but were more severe and protracted with the third. When she developed dark urine and jaundice, she sought medical care and liver tests showed mild hyperbilirubinemia accompanied by hepatocellular elevations in liver enzymes. Thereafter she improved rapidly and was asymptomatic with normal liver tests three weeks after her clinical presentation. Analysis by the sponsor of the product and independently by an FDA and NIH funded laboratory suggested that the responsible ingredient in the product was tara flour and its unique non-protein amino acid – baikiain. This case demonstrates the typical clinical course of “tara flour hepatotoxicity” with rapid onset of gastrointestinal symptoms after ingestion (within 4 to 12 hours) of abdominal pain and nausea followed in a few days by liver related symptoms of dark urine and jaundice, the laboratory results indicating a mild acute hepatocellular injury. Atypical in the current case was the presence of antinuclear antibody in moderately high titer, which persisted thereafter, and was probably a preexisting serologic abnormality. Risk factors for tara flour induced liver injury are not well defined; most patients affected were otherwise healthy women, without underlying liver disease or allergic conditions and not overweight or obese. Tara flour is most likely a direct hepatotoxin, and the dose and repeated exposure are probably the most important risk factors.

### Case 2. 55 year old woman with pain and jaundice after eating Daily Harvest’s French Lentil and Leek Crumbles [110-0199].(1)

A 55 year old woman developed abdominal pain, fatigue, and jaundice the day after her second use of Daily Harvest’s new frozen food product called “French Lentil and Leek Crumbles” for dinner. The first use had been 4 days earlier. Laboratory testing revealed a total bilirubin of 3.3 mg/dL, ALT 485 U/L, AST 518 U/L, alkaline phosphatase 138 U/L (R=16.7), and albumin 4.2 g/dL. She was generally healthy, had no history of medical illnesses, drug allergies, alcohol use, recent travel, or risk factors for viral hepatitis. She was taking no prescription medications or other herbal or dietary supplements. Tests for acute hepatitis A, B and C were negative. She was not hospitalized and did not undergo liver imaging or biopsy. Her symptoms improved rapidly, and when seen 12 days later, her serum total bilirubin was normal and liver enzymes were much improved (Table). In further follow up 1 and 3 months later, she was asymptomatic, and her liver tests were normal. Tests for ANA and SMA were negative, and IgG levels were normal. An abdominal ultrasound was normal without evidence of hepatic steatosis, biliary obstruction, or gall stones. Ultrasound elastography showed normal liver stiffness. At 10 months after onset, her liver tests remained normal, despite having started several over-the-counter supplements including garlic and resveratrol. Interestingly, both her husband and son also ate some of the crumbles with her, and both were found to have similar symptoms and liver test abnormalities (see Case 3).

#### Key Points

Medication: | French Lentil and Leek Crumbles
Pattern: | Hepatocellular (R=16.7)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 4 days to symptoms and jaundice
Recovery: | 2-3 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 day | Pre | First meal with FLLC
5 days | Pre | Second dinner with FLLC, symptoms
6 days | 1 days | 485 | 138 | 3.3 | Symptomatic, Jaundice
17 days | 12 days | 103 | 111 | 0.7 | Asymptomatic
5 weeks | 1 month | 25 | 88 | 0.6
3 months | 3 months | 18 | 69 | 0.6
10 months | 10 months | 29 | 76 | 0.6 | Asymptomatic
Normal Values | | <35 | <150 | <1.2

#### Comment

A family of husband, wife and two sons all had a meal that included Daily Harvest’s Frozen French Lentil and Leek Crumbles in which the wife, husband and one son developed evidence of liver injury 6 days after their first exposure and one day after the second. The son without evidence of injury did not eat the dish with the crumbles. The injury was an acute, short lived hepatocellular injury with mild jaundice that resolved within weeks after stopping the exposure. As is typical of other reported cases, the injury resolved rapidly and completely. There were no instances of acute liver failure, deaths from liver disease, or evidence for chronic injury reported with exposure to this commercial food product. Some patients underwent emergency cholecystectomy because of the prominence of abdominal pain and rapid onset of jaundice. Liver biopsies, done on a few patients, showed acute lobular hepatitis with spotty necrosis but no fibrosis, cholestasis, steatosis, or major degrees of necrosis.

### Case 3. 55 year old husband of Case 2 developed mild acute hepatitis after eating daily Harvest’s French Lentil and Leek Crumbles [110-0198].(1)

The 55 year old man whose wife developed acute, symptomatic hepatitis after Daily Harvest’s new frozen food product called “French Lentil and Leek Crumbles” (Case 2) ate the same meals with her and had similar but milder symptoms, feeling ill with a low grade fever, and then jaundice after the second meal. The first meal with the crumbles had been 4 days earlier. His initial laboratory test results included a total bilirubin of 5.5 mg/dL, ALT 369 U/L, AST 117 U/L, alkaline phosphatase 183 U/L (R=7.7). Tests for hepatitis A, B and C were negative. Like his wife, he was generally healthy, had no major medical illnesses except kidney stones and no history of liver disease, alcohol use, recent travel, or risk factors for viral hepatitis. He was not taking any prescription medications but took fish oil, multivitamins, and a probiotic. He had a history of allergic reactions to doxycycline and levofloxacin. Tests for acute hepatitis A, B and C were negative. He was not hospitalized and did not undergo liver imaging or biopsy. His symptoms improved rapidly, and when seen 12 day later serum total bilirubin was normal and liver enzymes were much improved (Table). In further follow up 1 and 3 months later, he was asymptomatic and liver tests were normal. The ANA was weakly positive (1:80), but SMA was negative, and IgG levels were normal. An abdominal ultrasound and transient elastography were normal without evidence of hepatic stiffness or steatosis, biliary obstruction, or gall stones. At 10 months after onset, his liver tests remained normal but transient elastography now showed evidence of mild hepatic steatosis (CAP 244). His BMI was 26.7. He had started several over-the-counter supplements including multivitamins and resveratrol.

#### Key Points

Medication: | French Lentil and Leek Crumbles
Pattern: | Hepatocellular (R=7.7)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 4 days to symptoms and jaundice
Recovery: | 2-3 weeks
Other medications: | Fish oil, multivitamins, probiotics

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 day | Pre | First meal with FLLC
5 days | Pre | Second dinner with FLLC, symptoms
6 days | 1 days | 369 | 183 | 5.5 | Symptomatic, jaundice
17 days | 12 days | 97 | 106 | 1.1 | Asymptomatic
5 weeks | 1 month | 26 | 80 | 0.9
3 months | 3 months | 32 | 59 | 1.0
10 months | 10 months | 40 | 59 | 0.8 | Asymptomatic
Normal Values | | <45 | <150 | <1.2

#### Comment

A family of husband, wife and one son all had a meal that included Daily Harvest’s Frozen French Lentil and Leek Crumbles, after which all three developed evidence of liver injury 6 days after their first exposure and one day after the second. Another son without evidence of injury had not eaten the dish with the crumbles. The injury was an acute, short lived hepatocellular injury with mild jaundice that rapidly resolved. The suspected cause was the protein-rich tara flour that had not been previously used in the Daily Harvest food program. Tara flour and collected samples of the lentil and leek crumbles has been shown to contain the non-protein amino acid baikiain which was shown to be a direct hepatotoxin in mouse models.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tara Flour – Daily Harvest’s French Lentil and Leek Crumbles

DRUG CLASS

Food, Dietary Supplement

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Baikiain | 31456-71-0 | C6-H9-NO2
3HMT | 300-48-1 | C10-H13-NO4
3HMP | 587-33-7 | C10-H13-NO3

## CITED REFERENCES

1 Choi G, Ahmad J, Navarro V, Thung W, Khan I, Avula B, Barnhart H, Stolz A; Drug-Induced Liver Injury Network. Characterization of an outbreak of acute liver injury after ingestion of plant-based food supplement. Aliment Pharmacol Ther 2024;00:1-5.38874448

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2024

Abbreviation: HDS, herbal and dietary supplements.

Electronic Code of Federal Regulations. Title 21. Part 182. Substances Generally Recognized As Safe. Available at: https://www.accessdata.fda.gov/scripts/cdrh/cfdocs/cfcfr/CFRSearch.cfm?CFRPart=182 (Listing of botanical and herbal products that are “generally recognized as safe” [GRAS] according to FDA criteria which permits them to be sold as over-the-counter supplements without prior proof of safety and efficacy: tara flour is not mentioned).
Hammond AC. Leucaena toxicosis and its control in ruminants. J Anim Sci. 1995;73:1487-92. (Leucaena is a tropical legume which caused an acute and chronic toxicosis in grazing livestock given the plant as forage, probable caused by the legume’s high content of the non-protein amino acid mimosine, and which can be prevented by introduction of gut bacteria which are found in areas of the world where Leucaena is indigenous, and which are capable of metabolizing mimosine). 7665380
Rosenthal GA. L-Canavanine: a higher plant insecticidal allelochemical. Amino Acids. 2001;21:319-30. (L-canavanine, a toxic non-protein amino acid and a structural analogue of arginine in which methylene group is replaced by oxygen, is produced by several species of legumes and is toxic to animals that graze on the plants that produce it). 11764412
Bence AK, Crooks PA. The mechanism of L-canavanine cytotoxicity: arginyl tRNA synthetase as a novel target for anticancer drug discovery. J Enzyme Inhib Med Chem. 2003;18:383-94. (The basis of toxicity produced by consumption of L-canavanine appears to be based on its loading onto the tRNA of arginine that is used by arginyl tRNA synthetase to produce proteins, in which L-canavanine replaces arginine and which have little or none of the expected enzymatic activity). 14692504
Nunn PB, Bell EA, Watson AA, Nash RJ. Toxicity of non-protein amino acids to humans and domestic animals. Nat Prod Commun. 2010;5:485-504. (Review of how some non-protein amino acids synthesized by plants can be toxic to other plants, microorganisms, insects, and higher animals including humans, examples include homoarginine, canavanine, mimosine, domoic acid and hypoglycine, some of which can cause disease in humans such as neuropathies, gastrointestinal illness, and liver injury). 20420333
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but tara flour and baikiain were not listed or mentioned). 22928722
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention baikiain, tara flour, or foods). 27402097
Sarasa SB, Mahendran R, Muthusamy G, Thankappan B, Selta DRF, Angayarkanni J. A brief review on the non-protein amino acid, gamma-amino butyric acid (GABA): its production and role in microbes. Curr Microbiol. 2020;77:534-544. (GABA is a non-protein amino acid produced by decarboxylation of glutamate that serves as the major negative neurotransmitter in the brain, having other functions in other organs and other organisms). 31844936
Negi VS, Pal A, Borthakur D. Biochemistry of plants N-heterocyclic non-protein amino acids. Amino Acids. 2021;53:801-812. (Plants synthesize a large number of heterocyclic non-protein amino acids which are a rich source of nitrogen, but also can be toxic to other organisms including foraging cattle, sheep and humans). 33950299
Chittiboyina AG, Ali Z, Avula B, Khan SI, Mir TM, Zhang J, Aydoğan F, et al. Is baikiain in tara flour a causative agent for the adverse events associated with the recalled frozen French Lentil & Leek Crumbles food product? - a working hypothesis. Chem Res Toxicol. 2023;36:818-821. (Analysis of the frozen French Lentil and Leek Crumbles product implicated in an outbreak of liver injury in May and June 2022 identified no evidence of toxic contaminants, microbial products, mycotoxins, or trace metals, but did identify components of tara flour one of which was the non-protein amino acid baikiain [1.5% w/w], which was not toxic in cell culture studies but did cause serum aminotransferase elevations and depletion of hepatic glutathione in mice treated with baikiain for 6 hours). 37255213
Chan SE, Smith CA. A food product as a potential serious cause of liver injury. Clin Toxicol (Phila). 2023;61:616-619. (Two Canadian women, ages 27 and 37, developed several episodes of abdominal pain, fatigue, and jaundice after ingesting smoothies that were made with tara flour [bilirubin 3.0 and 4.2 mg/dL, ALT 768 and ~460 U/L, Alk P 199 and ~ 230 U/L], with a short limited, rapidly resolving course). 37706365
Choi G, Ahmad J, Navarro V, Thung W, Khan I, Avula B, Barnhart H, Stolz A; Drug-Induced Liver Injury Network. Characterization of an outbreak of acute liver injury after ingestion of plant-based food supplement. Aliment Pharmacol Ther 2024;00:1-5. (Among 17 patients with French Lentil and Leek Crumbles induced liver injury, all occurring in May or June 2022, 14 were women, all were white, average age 41 years, often with abdominal pain within hours of ingestion and onset of liver injury 2-8 days later, mostly with hepatocellular enzyme pattern, mean bilirubin 2.2 mg/dL, and benign, self-limited course in all with no fatalities, and no chronicity: see Case Reports 1-3). 38874448

## OTHER REFERENCE LINKS

Recent References on Tara Flour: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tara+Flour%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tara Flour: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tara%20Flour)